# Heroin

## OVERVIEW

### Introduction

Heroin and opium are potent opiates that are currently banned in the United States and considered drugs of abuse. Persons who actively use heroin or opium often have liver disease due to substance abuse (alcoholic liver injury) or injection drug use (chronic hepatitis B, D or C), but neither heroin nor opium have been convincingly linked to clinically apparent liver injury or worsening of a concurrent liver disease.

### Background

Opium (o pee’ um) is a mixture of natural alkaloids derived from resin extracts from the seeds of the opium poppy, Papaver somniferum. The analgesic and mood altering effects of poppy extracts have been known for centuries and opium use has had profound effects on world history and many human lives. The natural opiates in opium include morphine, codeine and thebaine. Opium is typically taken by inhalation (opium pipe), but can also be taken orally.

Heroin (morphine diacetate) was developed in the 19th century as a derivative of morphine, the major alkaloid constituent of opium, and was initially thought to provide the potent analgesic effects without the euphoria and risk of psychological and physical dependency characteristic of opium. Heroin was the brand name for morphine diacetate and initially was sold over-the-counter as a cough suppressant. The abuse potential of heroin, however, rapidly became obvious and, by the 1920’s, heroin was the major drug of abuse in the United States, which led to its being made illegal and banned from clinical medicine. Both heroin and opium are potent agonists of the opiate receptors (predominantly the µ type receptor) which are found mostly in the central nervous system, but also in the lungs, heart, gastrointestinal tract and even on circulating white blood cells. Opium and heroin have many clinical effects, most strikingly euphoria, drowsiness, mental clouding and analgesia. While banned in the United States, heroin (known as its more correct chemical name of morphine diacetate) is available in other countries including the United Kingdom, but its use is severely restricted. The severe complications of heroin use are usually not due to its side effect profile, but to the unreliable sources, concentration and quality of the product.

### Hepatotoxicity

Despite centuries of use and abuse, opium and heroin have not been convincingly linked to cases of clinically apparent liver injury. Persons who use heroin or opium illicitly often have an underlying liver disease, due to other substance abuse behaviors (alcoholic liver disease) or parenteral exposures due to injection drug use (chronic hepatitis B, C or D). There is little evidence that opium or heroin use worsens these underlying liver diseases.

Likelihood score, Heroin: E (unlikely cause of clinically apparent liver injury).

Opium is a mixture of natural alkaloids, the major active ingredients being morphine and codeine. Heroin is a derivative of morphine and has no opiate activity, but is rapidly metabolized in the body to morphine. Heroin is the former brand name for morphine diacetate, which is more lipid soluble than morphine, for which reason it tends to have a faster onset of action and heightened potency.

Likelihood score, Opium: E (unlikely cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of opium and heroin are given in the Overview section of the Opioids.

Drug Class: Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

[None]

DRUG CLASS

Opioids

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Heroin | 561-27-3 | C21-H25-N-O5
Opium | 8008-60-4 | Unspecified Mixture of natural alkaloids including morphine and codeine | No Structure

## OTHER REFERENCE LINKS

1 Recent References on Heroin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=heroin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Heroin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=heroin)